# Selexipag

## OVERVIEW

### Introduction

Selexipag is prostacyclin receptor agonist that causes vasodilation in pulmonary vasculature and is used in the therapy of pulmonary arterial hypertension (PAH). Selexipag has been associated with a low rate of serum enzyme elevations during therapy, but has yet to be implicated in cases of clinically apparent acute liver injury.

### Background

Selexipag (se lex' i pag) is a selective prostacyclin receptor agonist that is used to treat pulmonary arterial hypertension (PAH). Inhibition of the prostaglandin receptors disrupts the intracellular pathways that lead to vasoconstriction, thus causing vasodilation. Because these receptors are found in highest concentration in the lungs, selexipag primarily causes vasodilation in the pulmonary vasculature and decreases pulmonary vascular pressure. In prospective, randomized controlled trials, selexipag was effective in alleviating symptoms, improving exercise capacity and prolonging the time to clinical worsening in patients with idiopathic PAH. Selexipag was approved for use in the United States in 2015 and experience with its use is limited. The current indications are for symptomatic PAH, classified as WHO group 1 (idiopathic). Use of selexipag in other forms of PAH (due to heart failure, thromboembolic disease, or pulmonary disease) should be considered experimental as its efficacy in these forms of PAH has not been adequately shown. Selexipag is available in tablets of 200, 400, 800, 1000, 1200, 1400 and 1600 µg under the brand name Uptravi. The recommended starting dose is 200 µg twice daily, which can be increased weekly by 200 µg twice daily to the highest tolerated dose up to 1600 µg twice daily. Common side effects include headaches, diarrhea, jaw pain, nausea, vomiting, myalgia, pain in the extremities and flushing. Uncommon, but potentially severe adverse reactions include pulmonary edema and hypersensitivity reactions.

### Hepatotoxicity

Selexipag is associated with a low rate of serum aminotransferase elevations (0% to 3%) that in clinical trials was similar to the rate among placebo recipients. These elevations were usually mild (rarely above 3 times ULN), transient and not associated with symptoms. There were no cases of serum enzyme elevations with jaundice in these preregistration clinical trials. Since licensure and more wide scale use, there have been no published reports of clinically apparent liver injury with jaundice associated with selexipag, but it has had limited general use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which selexipag might cause liver injury is not known. Selexipag is metabolized by the cytochrome P450 system (CYP 2C9 and 3A4), which may lead to production of a toxic intermediate and can also cause drug-drug interactions, particularly with cyclosporine A. One reason for its lack of hepatotoxicity may be that selexipag is administered in relatively low doses of 0.4 to 3.2 mg daily.

### Outcome and Management

The serum enzyme elevations associated with selexipag use have been mild-to-moderate and self-limited in course, often resolving despite drug continuation. There is no reason to believe that there is cross sensitivity to liver injury among the various therapies for PAH.

Drug Class: Pulmonary Arterial Hypertension Agents

Other Drugs in the Class: Ambrisentan, Bosentan, Riociguat, Macitentan; Prostacyclin Analogs, Epoprostenol, Iloprost, Treprostinil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Selexipag – Uptravi®

DRUG CLASS

Pulmonary Arterial Hypertension Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Selexipag)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Selexipag | 475086-01-2 | C26-H32-N4-O4-S | Selexipag chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 November 2016

Abbreviations used: PAH, pulmonary arterial hypertension

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, before the availability of selexipag).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on drug induced liver injury; clinical features of liver injury due to the selexipag are not specifically discussed).
Barnes PJ. Pharmacotherapy of pulmonary arterial hypertension. Pulmonary Pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1059-61. (Textbook of pharmacology and therapeutics).
Hill NS, Badesch D, Benza RL, D'Eletto TA, Farber HW, Gomberg-Maitland M, Hassoun PM, Preston I. Perspectives on oral pulmonary hypertension therapies recently approved by the U.S. Food and Drug Administration. Ann Am Thorac Soc 2015; 12: 269-73. (Review of recently approved drugs for pulmonary arterial hypertension [PAH] including macitentan, riociguat and oral treprostinil, only briefly mentions selexipag and does not discuss its side effects in any detail). 25590376
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to bosentan, but none to selexipag or other agents used primarily to treat pulmonary artery hypertension). 25754159
Kaufmann P, Okubo K, Bruderer S, Mant T, Yamada T, Dingemanse J, Mukai H. Pharmacokinetics and tolerability of the novel oral prostacyclin IP receptor agonist selexipag. Am J Cardiovasc Drugs 2015; 15: 195-203. (Among 64 healthy men given single or multiple doses of selexipag as a part of a phase 1 pharmacokinetic study, side effects included headache, but there were no changes in clinical laboratory tests). 25850750
Sitbon O, Channick R, Chin KM, Frey A, Gaine S, Galiè N, Ghofrani HA, et al.; GRIPHON Investigators. Selexipag for the Treatment of Pulmonary Arterial Hypertension. N Engl J Med 2015; 373: 2522-33. (Among 1156 patients with PAH treated with selexipag [200-1600 µg twice daily] or placebo for an average of 1.2 years, therapy was associated with improved outcomes and adverse events included headache [65% vs 3%] diarrhea [42% vs 2%], nausea [34% vs 2%], jaw pain [26% vs 6%] and myalgia [16% vs 6%]; no mention of ALT elevations or hepatotoxicity). 26699168
O'Connell C, Amar D, Boucly A, Savale L, Jaïs X, Chaumais MC, Montani D, et al. Comparative safety and tolerability of prostacyclins in pulmonary hypertension. Drug Saf 2016; 39: 287-94. (Review of the mechanism of action and safety of prostacyclins focusing upon selexipag, which is a non-prostanoid prostacyclin receptor agonist that can be taken orally and has similar adverse event profile to the inhaled, subcutaneous and intravenous forms of prostacyclins used to treat PAH; no mention of ALT elevations or hepatotoxicity). 26748508
Kaufmann P, Cruz HG, Krause A, Ulč I, Halabi A, Dingemanse J. Pharmacokinetics of the novel oral prostacyclin receptor agonist selexipag in subjects with hepatic or renal impairment. Br J Clin Pharmacol 2016; 82: 369-79. (Pharmacokinetic studies of single doses of selexipag in 17 patients with hepatic impairment found higher levels in those with greater impairment, but any clinically significant difference from normal would be mitigated by the recommended slow escalation of the dose based upon tolerance). 27062188
Velayati A, Valerio MG, Shen M, Tariq S, Lanier GM, Aronow WS. Update on pulmonary arterial hypertension pharmacotherapy. Postgrad Med 2016; 128: 460-73. (Review of the clinical features and outcome of PAH and current therapies including endothelin 1 antagonists, guanylate cyclase stimulators, and prostacyclin synthetics and analogues such as selexipag mentions that its tolerability “was consistent with other therapies targeting the prostacyclin pathway”). 27232660
Selexipag (Uptravi) for pulmonary arterial hypertension. Med Lett Drugs Ther 2016; 58 (1488): 21-3. (Concise review of the mechanism of action, clinical efficacy, safety and cost of selexipag shortly after its approval for use in the US, mentions the typical prostacyclin side effects but does not mention ALT elevations or hepatotoxicity). 26859660

## OTHER REFERENCE LINKS

1. Recent References on Selexipag: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Selexipag+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Selexipag: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Selexipag)